# Chaparral

## OVERVIEW

### Introduction

Chaparral is a botanical extract of the woody shrub known as creosote bush (Larrea tridentata) which has antioxidant activity and is claimed to have beneficial effects for many conditions from skin rash to cancer. Chaparral extracts have been linked to several cases of clinically apparent liver injury, some of which have led to acute liver failure and need for emergency liver transplantation.

### Background

Chaparral is prepared from the leaves of the evergreen desert shrub known as creosote bush (Larrea divaricata, subspecies tridentata), which is found in the southwestern United States and Mexico. The leaves are ground into a powdered extract that can be brewed into tea, which was the form used by Native Americans for centuries to treat various conditions such as respiratory illness, chickenpox, snakebite and arthritis pain. More recently, chaparral has been prepared as a botanical in pill forms as well as in salves for topical application and concentrated extracts to be brewed into tea. Chaparral extracts have multiple active ingredients, the most prominent being nordihydroguaiaretic acid (NDGA), which has potent antioxidant properties. NDGA is found in many plant species and has been used as a food additive in low concentrations. As a botanical extract, chaparral has been claimed to have multiple beneficial effects as a free radical scavenger and useful for weight loss, liver wellness, cleansing of blood, improving immunity (cancer, HIV infection) and treating skin disorders. Chaparral is also claimed to retard aging and aid in wellbeing. However, chaparral preparations have not been shown to be effective in any medical condition.

### Hepatotoxicity

Liver injury attributable to chaparral was first reported in 1990 and subsequently more than two dozen cases of clinically apparent liver injury attributed to chaparral have been published mostly from the United States, Canada and Australia. The time to onset varied from 3 weeks to several years, but was usually within 3 to 12 weeks of starting daily ingestion or increasing the daily dose. The pattern of injury was typically hepatocellular with an acute viral hepatitis-like presentation and marked elevations in serum aminotransferase levels, but minimal increase in alkaline phosphatase. Autoimmune and immunoallergic features were uncommon. Several reported cases have been severe and some have led to emergency liver transplantation, others appeared to result in cirrhosis. Subclinical cases and serum enzyme elevations without symptoms may occur but have not been well characterized. Despite the several reports of liver injury caused by chaparral, over-the-counter products with chaparral are still available commercially and on the internet. For unclear reasons, there have been no cases of liver injury clearly implicating chaparral published since 2005.

Likelihood score: B (likely but now rare cause of clinically apparent liver injury).

### Mechanism of Injury

Chaparral leaf extracts have many components but the most prominent is NDGA, an antioxidant which affects many intrahepatic pathways, including those involving cyclooxygenases and lipoxygenases. The rare cases of liver injury reported with chaparral use have had idiosyncratic features, and the rapid recurrence after reexposure and finding of eosinophils on liver biopsy suggest an allergic or immunological cause of injury. As with other reported herbal toxicities, the liver injury attributed to chaparral may have been due to contaminants or improperly prepared extracts.

### Outcome and Management

Hepatotoxicity from chaparral is rare, but some cases have been severe leading to acute liver failure. Other instances have been reported to lead to cirrhosis, but cases of chronic hepatitis or vanishing bile duct syndrome have not been reported. Recurrence after reexposure has occurred.

Drug Class: Herbal and Dietary Supplements

## CASE REPORT

### Case 1. Severe acute hepatitis due to chaparral.(1)

A 33 year old woman developed anorexia and nausea followed by jaundice 2 to 3 months after starting chaparral leaf (15 tablets per day) for a benign breast lump and general health on the advice of a friend. She decreased the number of tablets taken from 15 to 1 per day and her symptoms improved, but on increasing to 7 per day, she redeveloped nausea, jaundice, pale stools and increase in abdominal girth. Upon stopping chaparral leaf, her appetite returned but she continued to have fatigue and jaundice and sought medical advice. Her medical history was negative for liver disease, alcohol use or risk factors for viral hepatitis. Physical examination showed jaundice, ascites and peripheral edema without rash, fever or splenomegaly. Laboratory tests showed a total serum bilirubin of 12.0 mg/dL with marked elevations in serum aminotransferase levels (ALT 1385 U/L, AST 1285 U/L), with modest increases in alkaline phosphatase (285 U/L). Serum albumin was 2.8 g/dL and prothrombin time was 19 seconds. Tests for acute hepatitis A and B and Epstein Barr virus infection were negative as were autoantibodies. With stopping chaparral, she rapidly improved (Table) and after 3 weeks underwent liver biopsy, which showed severe hepatitis and submassive necrosis. She remained fatigued and had persistence of minor elevations in serum ALT for 12 months after stopping the botanical. In longterm follow-up, liver tests returned to normal.

#### Key Points

Medication: | Chaparral (1-15 tablets per day)
Pattern: | Hepatocellular (R=15.7)
Severity: | 4+ (jaundice, hospitalization, prolonged prothrombin time)
Latency: | 3 months
Recovery: | 12 months
Other medications: | None mentioned

#### Laboratory Values

Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Protime (seconds) | Other
1 week | 1285 | 285 | 12.0 | 19 | Admission
1.5 weeks | 708 | | 10.1 | 22
1 month | 317 | | 3.5 | 15 | Discharged
2 months | 123 | 110 | 1.2 | 12.6
3 months | 80 | 130 | 1.2 | 11.9
4 months | 60 | 120 | 0.9 | 12.6
12 months | 32 | 32 | 1.0 | 12.0 | Symptoms resolved
3 years | 21 | 36 | 0.5 | 12.0
Normal | <40 | <115 | <1.2 | <13

#### Comment

This initial case report of severe hepatitis attributed to chaparral use was published 7 years after its occurrence in 1983. A young woman developed a severe viral hepatitis-like syndrome 3 months after starting chaparral and had a temporary improvement on lowering the dose, and subsequent worsening with increasing it. Serum liver tests were not available from these periods of dose adjustment, but the clinical history suggested an association of disease severity with dosage and a positive rechallenge. When she presented to medical evaluation, she had evidence of severe hepatitis with jaundice and marked serum aminotransferase elevations along with ascites and prolongation of the prothrombin time. She began to improve between 1 and 2 weeks after stopping chaparral. A liver biopsy documented the severity of the liver injury (submassive necrosis with an estimated 60% loss of parenchyma). Symptoms and minor serum enzyme elevations persisted for at least 4 months after stopping, with full documentation of resolution when she was seen a year after stopping chaparral. The component of chaparral leaf extracts that is responsible for hepatotoxicity is not known; features of the disease suggest that the liver injury is idiosyncratic rather than a direct toxic effect.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Chaparral – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Chaparral | 84603-70-3 | Herbal mixture | Not applicable

## CITED REFERENCES

1 Katz M, Saibil F. (1990). Herbal hepatitis: subacute hepatic necrosis secondary to chaparral leaf. J Clin Gastroenterol.

## ANNOTATED BIBLIOGRAPHY

References updated: 25 May 2022

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; mentions that chaparral leaf has led to 10 reported cases of hepatocellular injury, including at least one case of acute liver failure).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbs and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58.
(Review of hepatotoxicity of herbal and dietary supplements [HDS] describes results of the FDA analysis of cases of liver injury attributed to chaparral, which included cases of acute liver failure and others resulting in cirrhosis).
Katz M, Saibil F. (1990). Herbal hepatitis: subacute hepatic necrosis secondary to chaparral leaf. J Clin Gastroenterol. (33 year old woman developed nausea followed by jaundice 3 months after starting chaparral, improving on lowering the dose and worsening on increasing [bilirubin 12.0 mg/dL, ALT 1385 U/L, protime 19 sec], with slow improvement on stopping, resolving in 12 months: Case 1).
Centers for Disease Control (CDC). (1992). Chaparral-induced toxic hepatitis--California and Texas, 1992. MMWR Morb Mortal Wkly Rep. (Two patients with severe hepatitis attributed to ingestion of chaparral; a 42 year old man and 41 year old woman who presented with jaundice 6 and 11 weeks after starting chaparral [bilirubin 16.6 and 30 mg/dL, AST 1077 and 3560 U/L, Alk P 133 and normal], resolving within 8 and 12 weeks of stopping).
Smith BC, Desmond PV. (1993). Acute hepatitis induced by ingestion of the herbal medication chaparral. Aust N Z J Med. (36 year old woman developed jaundice and pruritus 8 weeks after starting chaparral [peak bilirubin 19.1 mg/dL, AST 674 U/L, Alk P 242 U/L], with resolution 4 months after stopping).
Alderman S, Kailas S, Goldfarb S, Singaram C, Malone DG. (1994). Cholestatic hepatitis after ingestion of chaparral leaf: confirmation by endoscopic retrograde cholangiopancreatography and liver biopsy. J Clin Gastroenterol. (45 year old woman developed jaundice 2 months after starting chaparral for alcohol avoidance [bilirubin 11.6 rising to 35 mg/dL, ALT 1611 U/L, Alk P 265 U/L], with temporary worsening, prednisone therapy and eventual recovery over next 3 months).
Gordon DW, Rosenthal G, Hart J, Sirota R, Baker AL. (1995). Chaparral ingestion. The broadening spectrum of liver injury caused by herbal medications. JAMA. (60 year old woman developed jaundice 10 months after starting chaparral [and 3 weeks after dose increase] with progressive liver failure [bilirubin 12.4 rising to 35.5 mg/dL, ALT 341 U/L, Alk P 186 U/L, protime 15.9 rising to 28 seconds], undergoing successful emergency liver transplantation).
Stashower ME, Torres RZ. (1995). Chaparral and liver toxicity. JAMA. (Letter in response to Gordon [1995] pointing out that chaparral is not an herb, but a woody shrub).
Ippen H. (1995). Chaparral and liver toxicity. JAMA. (Letter in response to Gordon [1995], questioning the actual plant being described, the term chaparral referring to several species and suggesting use of exact botanical names: Larrea divaricata, subsp tridentata).
Fleiss PM. (1995). Chaparral and liver toxicity. JAMA. (Letter in response to Gordon [1995], questioning whether chaparral was the cause of the liver injury and not diltiazem [which was also being taken] or a contaminant of the botanical product).
Batchelor WB, Heathcote J, Wanless IR. (1995). Chaparral-induced hepatic injury. Am J Gastroenterol. (Two patients; 71 year old man developed jaundice and ascites 2 months after starting daily chaparral intake [bilirubin 17.8 mg/dL, AST 385 U/L, Alk P 149 U/L], resolving within 2 months of stopping and recurring 1 month after restarting [bilirubin 9.9 mg/dL, AST 767 U/L, Alk P 304 U/L]; 43 year old woman developed nausea and then jaundice 6 weeks after starting chaparral for headaches [bilirubin 9.7 mg/dL, AST 1612 U/L, Alk P 129 U/L], resolving within 4 months of stopping).
Sheikh NM, Philen RM, Love LA. (1997). Chaparral-associated hepatotoxicity. Arch Intern Med. (Summary of 13 reports of hepatotoxicity reported to the FDA between 1992-4: 11 women and 2 men, ages 25 to 60 years, taking 8 different chaparral preparations [mostly single product capsules], for 3 to 12 weeks in most, but for 1 to many years in some, for various indications [weight loss, acne, allergies, blood thinning, cleanser, arthritis and asthma], typically presenting with jaundice and marked ALT and AST elevations but minor increases in Alk P, resolving in most but 2 required liver transplant and 4 developed cirrhosis).
Shad JA, Chinn CG, Brann OS. (1999). Acute hepatitis after ingestion of herbs. South Med J. (Two cases; 33 year old woman developed ALT elevations [488 U/L] within 8 weeks of starting “bee pollen”, resolving within 6 weeks of stopping; 69 year old man developed jaundice 6 weeks after starting herbal mixture, including chaparral and bee pollen [bilirubin 27.2 mg/dL, ALT 1081 U/L, Alk P 272 U/L], resolving within 8 weeks of stopping).
Chitturi S, Farrell GC. (2001). Drug-induced cholestasis. Semin Gastrointest Dis. (Review of hepatotoxicity manifested by prominent cholestatic features; discusses chaparral although the usual presentation is as an acute hepatitis-like syndrome rather than cholestasis).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury due to herbals, including discussion of potential risk factors, and herb-drug interactions; chaparral is listed and discussed as potential cause of acute liver failure and cirrhosis; the specific hepatotoxic compound in chaparral extracts is unknown).
Haller CA, Dyer JE, Ko R, Olson KR. (2002). Making a diagnosis of herbal-related toxic hepatitis. West J Med. (Two cases demonstrating the difficulties of identifying the toxic component of herbals; 42 year old woman developed fatigue 10 weeks after starting 3 herbal medications [bilirubin 1.2 mg/dL, ALT 3386 U/L, Alk P 100 U/L], ultimately attributed to Jin Bu Huan; 39 year old woman developed acute liver failure after taking multiple herbals [bilirubin 42.7 mg/dL, ALT 349 U/L, INR 3.9] believed to be due to chaparral).
Schiano TD. (2003). Hepatotoxicity and complementary and alternative medicines. Clin Liver Dis. (Comprehensive review of herbal associated hepatotoxicity, including common patterns of presentation; discusses chaparral as a potential cause of acute liver failure and cirrhosis).
Estes JD, Stolpman D, Olyaei A, Corless CL, Ham JM, Schwartz JM, Orloff SL. (2003). High prevalence of potentially hepatotoxic herbal supplement use in patients with fulminant hepatic failure. Arch Surg. (Among 20 patients undergoing liver transplantation for acute liver failure at two US medical centers during 2001-2, 10 were potentially caused by herbals; 1 was attributed to chaparral).
Pittler MH, Ernest E. (2003). Systematic review: hepatotoxic events associated with herbal medicinal products. Aliment Pharmacol Ther. (Systematic review of published cases of hepatotoxicity due to herbal medications listing 3 cases due to chaparral).
Kauma H, Koskela R, Mäkisalo H, Autio-Harmainen H, Lehtola J, Höckerstedt K. (2004). Toxic acute hepatitis and hepatic fibrosis after consumption of chaparral tablets. Scand J Gastroenterol. (22 year old woman developed pruritus and jaundice 8 weeks after starting chaparral [2 tablets daily] [bilirubin 11.8 mg/dL, ALT 2871 U/L, Alk P511 U/L], with rapid improvement on stopping, but recurrence within 2 weeks of restarting [bilirubin 8.8 mg/dL, ALT 1084 U/L, Alk P 379 U/L], resolving within 2 months of finally stopping).
Pak E, Esrason KT, Wu VH. (2004). Hepatotoxicity of herbal remedies: an emerging dilemma. Prog Transplant. (Review of hepatotoxicity of herbal medications stressing the recent rise in numbers of cases; summarizing a single case report and FDA summary of chaparral hepatotoxicity).
Seeff LB. (2007). Herbal hepatotoxicity. Clin Liver Dis. (Review of herbals as a cause of hepatotoxicity, with specific discussion of chaparral as a cause of acute hepatitis, acute liver failure and cirrhosis).
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. (2008). Rev Esp Enferm Dig. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, none due to chaparral).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 9% of cases were attributed to herbal medications, none due to chaparral).
Navarro VJ. (2009). Herbal and dietary supplement hepatotoxicity. Semin Liver Dis. (Overview of the regulatory environment, clinical patterns, and future directions in research with HDS; chaparral has been linked to hepatotoxicity by a series of case reports).
Stickel F, Schuppan D. (2007). Herbal medicine in the treatment of liver diseases. Dig Liver Dis. (Review of current understanding of liver injury from herbals and dietary supplements, focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, Noni juice, Chinese herbs, vitamin A and anabolic steroids).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (Systematic tabulation of the literature on hepatotoxicity of herbals and lists five publications on chapparal).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Review of HDS associated hepatotoxicity with discussion of chaparral which was used in the form of teas, capsules, tablets and salves and perceived to have antimicrobial and antioxidant activities, but subsequently associated with more than a dozen cases of liver injury including two requiring liver transplantation and 4 resulting in cirrhosis).
Teschke R, Schulze J, Schwarzenboeck A, Eickhoff A, Frenzel C. (2013). Herbal hepatotoxicity: suspected cases assessed for alternative causes. Eur J Gastroenterol Hepatol. (Review of the literature of case series of suspected HDS related liver injury found evidence of other explanations for the liver injury in 19 of 23 publications involving 278 of 573 patients [49%], and that these other diagnoses weakened the causality assessment in most instances).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, but none were attributed to a Move Free product or Chinese skullcap).
Licata A, Macaluso FS, Craxì A. (2013). Herbal hepatotoxicity: a hidden epidemic. Intern Emerg Med. (Review and commentary on herbal hepatotoxicity discusses Larrea tridentata as being linked to at least 13 cases of liver injury with different clinical patterns including acute liver failure and chronic injury resulting in cirrhosis).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment; mentions that chaparral has been linked to cases of liver injury some of which were severe enough to require liver transplantation).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to a chaparral containing product).
Navarro VJ, Lucena MI. (2014). Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis. (Review of HDS induced liver injury including regulatory problems, difficulties in diagnosis and causality assessment, mentions that chaparral has been associated with severe liver injury and liver failure).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of possible beneficial as well as harmful effects of herbal products on the liver mentions that there have been numerous reports of liver injury from chaparral ranging from elevated enzyme levels alone to fulminant hepatitis).
Stickel F, Shouval D. (2015). Hepatotoxicity of herbal and dietary supplements: an update. Arch Toxicol. (Extensive review of liver injury due to HDS mentions that Herbalife has been implicated in 54 cases of liver injury, 7 with a positive rechallenge, but that the cause of the injury remains unknown and that few cases have been published since 2011; does not mention Move Free products).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], none of which were primarily attributed to chaparral: see Navarro [2014]).
Reddy S, Mishra P, Qureshi S, Nair S, Straker T. (2016). Hepatotoxicity due to red bush tea consumption: a case report. J Clin Anesth. (37 year old man with acute appendicitis was found to have abnormal liver tests and had consumed up to ten cups daily of “red bush tea”[bilirubin 0.6 mg/dL, ALT 165 U/L, AST 606 U/L, Alk P 87 U/L, INR 1.0, platelets 49,000/ µL], underwent uneventful appendectomy and liver tests improved rapidly with stopping tea).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists nine publications of case reports and case series implicating chaparral in causing liver injury although none in the previous 20 years).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], none were attributed to chaparral).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while none were attributed to chaparral).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [n=91], green tea [90] Herbalife products [64], kava [62] and greater celandine [48]; chaparral was listed as the cause of 24 cases, mostly from the United States, Canada and Australia characterized by latency of 3 to 12 weeks and acute hepatocellular injury that is usually self-limited but can be fatal).

## OTHER REFERENCE LINKS

1 Recent References on Chaparral: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=chaparral+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Chaparral: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=chaparral)